# Nevirapine

## OVERVIEW

### Introduction

Nevirapine is a nonnucleoside reverse transcriptase inhibitor used in combination with other agents in the therapy of human immunodeficiency virus (HIV) infection and the acquired immune deficiency syndrome (AIDS). Nevirapine is associated with a high rate of serum aminotransferase elevations during therapy and is a well established cause of acute, clinically apparent liver injury.

### Background

Nevirapine (ne vir' a peen) is a nonnucleoside inhibitor of the HIV polymerase enzyme and acts by binding to and disrupting the active catalytic site of the viral polymerase, causing a conformational change in the three dimensional structure of the enzyme. Nevirapine is a potent inhibitor of HIV replication and is a major component of highly reactive antiretroviral therapy (HAART) commonly being given in combination with one or two nucleoside reverse transcriptase inhibitors. Nevirapine was approved for use in HIV infection in the United States in 1996 and is currently used in a high proportion of HAART regimens. Nevirapine is available in generic forms and under the brand name of Viramune in standard tablets of 200 mg and extended release tablets of 400 mg. The usual adult dose is 200 mg once daily for 2 weeks followed by standard 200 mg tablets twice daily or extended release tablets of 400 mg once daily. Nevirapine is used in combination with other antiretroviral agents and is available in combinations with zidovudine and lamivudine. An oral suspension is also available for use in pediatrics. Common side effects include rash (~20%), nausea, fatigue, fever and headache. Uncommon but severe adverse reactions include hepatotoxicity, severe skin reactions, hypersensitivity reactions, immune reconstitution syndrome, and abnormal fat distribution.

### Hepatotoxicity

Therapy with nevirapine is associated with significant elevations in ALT levels (above 5 times the upper limit of normal) in 4% to 20% of patients and symptomatic elevations in 1% to 5% of patients. These elevations are usually transient but can be symptomatic and may require discontinuation of nevirapine. Risk factors for ALT elevations include preexisting liver disease due to HCV or HBV, and possibly female gender, CD4 T cell counts above 250/μL, and absence of HIV infection (such as when given for prophylaxis after an acute exposure). In addition, among the more than 20 antiretroviral agents in current use, nevirapine is perhaps the most common cause of serious, clinically apparent acute liver injury. The frequency of clinically apparent liver injury due to nevirapine is as high as 1%, with fatalities occurring in approximately 0.1% of treated patients. The onset of injury is almost always within the first 6 to 8 weeks of therapy (average 3 weeks) and presenting symptoms are typically abdominal pain and fatigue, followed by fever, rash and jaundice. A large proportion of patients have features of immunoallergic hepatitis (nevirapine hypersensitivity syndrome) with rash, fever and eosinophilia (Cases 2 and 3). Autoantibodies are not common. Most instances have cholestatic features, but initial serum enzyme elevations may be hepatocellular in pattern, particularly in severe cases (Case 1). The associated rash can be severe and compatible with toxic epidermal necrosis or Stevens-Johnson syndrome. Some cases of clinically apparent hepatotoxicity due to nevirapine are not associated with signs of hypersensitivity, and these generally present after the first 8 weeks of therapy but can be severe and even fatal.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatic injury with nevirapine is believed to be immunoallergic. Hepatic injury is more common among women than men and in patients with higher CD4 T cell counts and has been associated with specific HLA types. However, not all cases of nevirapine hepatotoxicity may be immunoallergic in origin, particularly those with a longer latency period to onset. Nevirapine has extensive hepatic metabolism and is a substrate for CYP 2B6 and 3A4 and a potent inducer of these enzymes, features that favor potential production of a toxic intermediate that might cause liver injury.

### Outcome and Management

Nevirapine hepatotoxicity can be severe and fatal instances as well as cases requiring emergency liver transplantation have been described. In large case series, nevirapine is usually listed in the major causes of drug induced acute liver failure. The nevirapine product label includes a boxed warning about hepatotoxicity and recommends regular monitoring for liver test abnormalities before and at least monthly for the first 18 weeks of treatment. Some degree of ALT elevation arises in up to 25% of patients treated with nevirapine-containing antiretroviral regimens which usually resolve even with continuation of therapy. Nevirapine should be promptly discontinued if serum aminotransferase levels rise about 10 times ULN or are persistently above 5 times ULN or if accompanied by bilirubin elevations or symptoms of hepatitis. Patients with nevirapine hepatotoxicity should not be restarted on treatment. There appears to be little if any cross sensitivity to hepatotoxicity among the other antiretroviral agents, including other nonnucleoside reverse transcriptase inhibitors such as efavirenz, etravine, delavirdine and rilpivirine.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nonnucleoside Reverse Transcriptase Inhibitors: Delavirdine, Doravirine, Efavirenz, Etravirine, Rilpivirine

## CASE REPORTS

### Case 1. Severe acute hepatitis due to nevirapine.(1)

A 28 year old woman with HIV infection [CD4 count 255 cells/µL; HIV level 100,000 copies/mL] was started on antiretroviral therapy consisting of zidovudine, lamivudine and nevirapine and developed nausea and headache followed by jaundice and pruritus 6 weeks later. On presentation, she was jaundiced without fever or rash. There were marked elevations in serum aminotransferase levels with bilirubin of 11.2 mg/dL, a prothrombin index of 28%, no eosinophilia and mild lactic acidemia (Table). Liver tests had been normal before therapy. Tests for hepatitis A, B, C and E were negative as were auto-antibodies. Serum copper and ceruloplasmin levels were normal. Ultrasonography and CT scans of the abdomen were unremarkable. She had taken acetaminophen [3 g/day] for the 2 days before presentation and acetaminophen levels were 11 mg/L. Nevirapine was stopped and she was given infusions of N-acetylcysteine. Nevertheless, she deteriorated rapidly developing stage 2 encephalopathy. A liver biopsy showed massive necrosis with portal inflammation and bile duct proliferation. There was no microvesicular fat, and no findings of chronic liver disease. Serum aminotransferase levels fell but the prothrombin index worsened and she underwent liver transplantation 3 days after admission. She had an uneventful post-transplant course and was placed on efavirenz, abacavir and lamivudine 15 days later. In follow up 3 months later, her liver tests were normal.

#### Key Points

Medication: | Nevirapine (200 mg daily)
Pattern: | Hepatocellular (R>100)
Severity: | 5+ (liver transplantation)
Latency: | 6 weeks
Recovery: | None
Other medications: | Lamivudine, zidovudine, 2 days of acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | | 20 | | Normal
0 | Pre | Nevirapine, lamivudine and zidovudine started
6 weeks | 0 | 12578 | 340 | 11.2 | INR=3.2
| 1 day | 1804 | | | INR=6.3, Encephalopathy
Emergency liver transplantation done on day 3 of admission
7 weeks | 4 days | 2650
5 months | 3 months | 35
Normal Values | | <40 | <130 | <1.2

#### Comment

A typical timing for onset of nevirapine hepatotoxicity with a hepatocellular pattern of serum enzyme elevations. Unlike many cases, there were no signs or findings of hypersensitivity (rash, fever, lymphadenopathy, facial edema, eosinophilia). Furthermore, she had taken full doses of acetaminophen for two days before presentation and there may have been an element of superimposed acetaminophen hepatotoxicity (explaining the initial, very high ALT levels and marked centrolobular necrosis). In follow up, she was treated with efavirenz (another nonnucleoside reverse transcriptase inhibitor) without evidence of recurrence of hepatic injury.

### Case 2. Acute immunoallergic hepatitis due to nevirapine.(2)

A 26 year old pregnant woman with HIV infection developed fever and skin rash 6 weeks after starting antiretroviral therapy with nevirapine, lamivudine and zidovudine. Before therapy, her CD4 count was 614 cells/µL, HIV RNA level was 1642 copies/mL, and liver tests were normal. On admission at 32 weeks gestation, she was febrile and jaundiced and had a diffuse urticarial rash. Laboratory tests showed eosinophilia and a cholestatic pattern of serum enzyme elevation (Table). Tests for hepatitis A, B and C and for EBV and CMV infection were negative, as were autoantibodies. Ultrasound of the liver showed no evidence of obstruction. Nevirapine was stopped and she was given corticosteroids. Over the next few days she continued to worsen and emergency Caesarian section was done. Thereafter, she began to improve and was discharged 4 days after delivery. In follow up, she was asymptomatic, had normal liver test results and the child was well and without evidence of HIV infection.

#### Key Points

Medication: | Nevirapine (200→400 mg daily)
Pattern: | Cholestatic (R=1.6)
Severity: | 4+ (jaundice, hospitalization and features of hepatic failure)
Latency: | 6 weeks
Recovery: | Complete
Other medications: | Lamivudine, zidovudine, 2 days of acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 14 | | 0.4
2 weeks | | 14 | 77 | 0.4
6 weeks | 0 | 235 | 257 | 12.0 | INR 2.4, given betamethasone
| 2 days | 404 | 175 | 15.3 | INR 3.6, fresh frozen plasma
| 4 days | 966 | 201 | 19.4 | Fever, 20% eosinophilia
Emergency Caesarian Section
7 weeks | 6 days | 746 | 239 | 20.2 | Oral prednisone
| 8 days | 696 | 466 | 16.9
8 weeks | 2 weeks | 509 | 500 | 7.0 | Discharged
6 months | 4 months | 18 | 73 | 0.4
Normal Values | | <61 | <106 | <1.2

#### Comment

A very characteristic example of the DRESS syndrome (drug rash with eosinophilia and systemic symptoms) due to nevirapine in a woman with HIV infection and a CD4 count above 250/µL. The associated immunoallergic hepatitis was severe with bilirubin levels reaching 20 mg/dL and prolongation of prothrombin time. While the clinical course was also compatible with pregnancy associated HELPP syndrome, the timing and immunoallergic features suggest that nevirapine was the major cause. Women may be more susceptible to the immunoallergic hepatitis caused by nevirapine, and pregnancy may increase the risk further. Corticosteroids are often used in patients with severe immunoallergic hepatitis and they appear to improve many of the manifestations of hypersensitivity, but their efficacy in altering the ultimate outcome of the liver injury has not been proven.

### Case 3. Acute immunoallergic hepatitis due to nevirapine.(3)

A 31 year old man with HIV-HCV coinfection developed a diffuse maculopapular rash within 7 days of switching antiretroviral therapy from zidovudine and didanosine to nevirapine (200 mg daily), lamivudine (150 mg twice daily) and stavudine (40 mg twice daily). All three drugs were stopped and the rash resolved rapidly. Ten days later, all three agents were restarted, but rash and fever (to 39^o^ C) appeared two days later followed by myalgias, dark urine, jaundice and pruritus. Laboratory testing showed eosinophilia, elevations in serum enzymes and hyperbilirubinemia (Table). All three drugs were stopped, and he was monitored carefully. Ultrasound of the abdomen showed no evidence of biliary obstruction. Symptoms resolved and laboratory abnormalities resolved rapidly. Serum ALT levels, which had been minimally elevated before nevirapine therapy, returned to the pretreatment levels. He was restarted on lamivudine, stavudine and indinavir without reappearance of rash or jaundice.

#### Key Points

Medication: | Nevirapine (200 mg daily)
Pattern: | Cholestatic (R=1.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 20 days from first exposure; 3 days on reexposure
Recovery: | Complete by 3 weeks
Other medications: | Lamivudine, stavudine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 63 | 75 | 0.3 | Known chronic hepatitis C
1 week | | Rash: Antiretroviral drugs stopped
3 weeks | | Nevirapine, lamivudine and stavudine restarted
3 days | 0 | 224 | 501 | 12.7 | Rash, fever, 30% eosinophils
10 days | 7 days | 163 | 263 | 2.9
23 days | 20 days | 55 | 85 | 0.2
Normal Values | | <40 | <115 | <1.2

#### Comment

A very characteristic example of drug rash with eosinophilia and hepatic injury due to a nevirapine in a patient with HIV and HCV infection. The injury was characterized by a mild cholestatic pattern with rapid recovery with stopping therapy. While a large proportion of patients develop rash with nevirapine therapy (usually within the first 3 weeks of starting), only a proportion (~10 to 20%) develop serum ALT elevations at the time of the rash, and an even smaller proportion (~1 to 5%) develop clinically apparent liver injury and jaundice. Hepatitis C may predispose to clinically apparent liver injury but, in this instance, HCV did not appear to play a role. Persons who develop a rash on nonnucleoside reverse transcriptase inhibitors should be monitored for serum ALT levels; but often can remain on therapy, the rash resolving despite continuing the agent. The presence of marked serum ALT elevations or symptoms should lead to stopping therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nevirapine – Generic, Viramune®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nevirapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nevirapine | 129618-40-2 | C15-H14-N4-O

## CITED REFERENCES

1 Buyse S, Vibert E, Sebagh M, Antonini T, Ichai P, Castaing D, Samuel D, Duclos-Vallée JC. (2006). Liver transplantation for fulminant hepatitis related to nevirapine therapy. Liver Transpl.
2 Knudtson E, Para M, Boswell H, Fan-Havard P. (2003). Drug rash with eosinophilia and systemic symptoms syndrome and renal toxicity with a nevirapine-containing regimen in a pregnant patient with human immunodeficiency virus. Obstet Gynecol.
3 Claudio GA, Martin AF, de Dios Perrino S, Velasco AA. (2001). DRESS syndrome associated with nevirapine therapy. Arch Intern Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 May 2020

Abbreviations: AIDS, acquired immunodeficiency syndrome; DRESS, drug rash with eosinophilia and systemic symptoms; HIV, human immunodeficiency virus.
Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents mentions that nevirapine is the antiretroviral agent that is most commonly implicated in causing liver injury).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-58. (Textbook of pharmacology and therapeutics).
NIH. HIV Info. https://clinicalinfo.hiv.gov/en/guidelines (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Havlir D, Cheeseman SH, McLaughlin M, Murphy R, Erice A, Spector SA, Greenough TC, et al. (1995). High-dose nevirapine: safety, pharmacokinetics, and antiviral effect in patients with human immunodeficiency virus infection. J Infect Dis. (Among 21 patients with HIV infection given 400 mg of nevirapine daily for 12 weeks, 48% developed rash, usually within first 3 weeks and not in association with ALT elevations, which arose in 3 patients [14%]).
Carr A, Vella S, de Jong MD, Sorice F, Imrie A, Boucher CA, Cooper DA, Dutch-Italian-Australian Nevirapine Study Group. (1996). A controlled trial of nevirapine plus zidovudine versus zidovudine alone in p24 antigenaemic HIV-infected patients. AIDS. (Among 25 patients given nevirapine and zidovudine, 8 developed fever and rash [32%] usually within 28 days; one had ALT elevations above 5 times ULN; all resolved with stopping).
D’Aquila RT, Hughes MD, Johnson VA, Fischl MA, Sommadossi JP, Liou SH, Timpone J, et al. (1996). Nevirapine, zidovudine, and didanosine compared with zidovudine and didanosine in patients with HIV-1 infection. Ann Intern Med. (Trial of zidovudine and didanosine with or without nevirapine for 48 weeks in 398 patients with HIV infection; severe rash occurred in 2% without vs 9% with nevirapine, and AST elevations >5 times normal occurred in 4.5% vs 8%).
Reiter GS. (1997). Hepatitis in an HIV-infected man. AIDS Clin Care. (28 year old man developed malaise and fever 3 weeks after starting nevirapine [with stavudine and lamivudine] with subsequent jaundice [bilirubin 11.8 rising to 17.9 mg/dL, ALT 480 U/L, Alk P 133 U/L], ultimately resolving after stopping medications).
Havlir DV, Lange JM. New antiretrovirals and new combinations. AIDS 1998; 12 Suppl A: S165-74. (Review of new agents, including nelfinavir, nevirapine, delavirdine, efavirenz and abacavir; most significant toxicities discussed include diarrhea for nelfinavir, rash and hepatitis for nevirapine, rash for delavirdine).
Warren KJ, Boxwell DE, Kim NY, Drolet BA. (1998). Nevirapine-associated Stevens-Johnson syndrome. Lancet. (31 year old man developed severe rash 10 days after starting nevirapine [with lamivudine and zidovudine] with fever, oral and corneal ulcers [6% eosinophilia, normal “chemistries”], mentions that FDA has received 20 reports of hospitalization due to rash caused by nevirapine).
Montaner JS, Reiss P, Cooper D, Vella S, Harris M, Conway B, Wainberg MA, et al., INCAS Study Group. (1998). A randomized double-blind trial comparing combinations of nevirapine, didanosine, and zidovudine for HIV-infected patients. The INCAS Trial. JAMA. (Among 151 patients in a randomized controlled trial, rash occurred in 22% on nevirapine [no Stevens Johnson syndrome], 27% had liver test elevations, 5% required stopping, but all ultimately resolved).
Bourezane Y, Salard D, Hoen B, Vandel S, Drobacheff C, Laurent R. (1998). DRESS (drug rash with eosinophilia and systemic symptoms) syndrome associated with nevirapine therapy. Clin Infect Dis. (32 year old man with HIV infection developed rash 15 days and fever 34 days after starting nevirapine, stavudine and indinavir [bilirubin not mentioned, ALT 1072 U/L, Alk P 229 U/L, 18% eosinophils], resolving promptly with stopping nevirapine and corticosteroid therapy).
Pollard RB, Robinson P, Dransfield K. (1998). Safety profile of nevirapine, a nonnucleoside reverse transcriptase inhibitor for the treatment of human immunodeficiency virus infection. Clin Ther. (Experience in 906 adults and 468 children in clinical trials of nevirapine; rash occurred in 16%, which was reduced by starting with lower doses; ALT elevations >250 U/L occurred in 11%; clinical hepatitis in 1% usually in first 5 weeks; no additional cases in long term treatment groups).
Leitze Z, Nadeem A, Choudhary A, Saul Z, Roberts I, Manthous CA. (1998). Nevirapine-induced hepatitis treated with corticosteroids?. AIDS. (36 year old with HIV and HCV infection developed fever and rash 4 weeks after starting nevirapine [bilirubin 2.0 mg/L, ALT 1424 U/L, Alk P 777 U/L, 13% eosinophils], responding rapidly to methylprednisolone).
Ho TTY, Wong KH, Chan KCW, Lee SS. (1998). AIDS. (5 of 8 Chinese patients treated with nevirapine developed rash within 8 weeks of starting: 4 had abnormal liver tests [bilirubin 1.3-7.3 mg/dL, ALT 93-266 U/L, Alk P 48-608 U/L], all resolving upon stopping drug).
Cattelan AM, Erne E, Salatino A, Trevenzoli M, Carretta G, Meneghetti F, Cadrobbi P. (1999). Severe hepatic failure related to nevirapine treatment. Clin Infect Dis. (61 year old man developed jaundice, fever and rash 2 weeks after starting nevirapine [bilirubin 3.6 mg/dL, ALT 337 U/L, Alk P 237 U/L, protime 35%, eosinophils 46%], developing moderate ascites, but recovering within 2 months of stopping).
Orenstein R, LeGall-Salmon E. (1999). HIV treatment-associated hepatitis. AIDS Read. (Review of antiretrovirals and liver injury; nevirapine causes hepatitis in 8-28% of patients, causing >5 fold elevation in ALT in 15% of patients and being cause of withdrawal in 5% in INCAS trial).
Wetterwald E, Le Cleach I, Michel C, David F, Pevuz J. (1999). Nevirapine-induced overlap Stevens-Johnson syndrome/toxic epidermal necrolysis. Br J Dermatol. (Two cases of Stevens-Johnson toxic epidermal necrolysis-like syndromes during nevirapine therapy; 35 and 40 year old HIV infected patients developed generalized rash and blisters with oral involvement 13 and 25 days after starting nevirapine; ALT levels >4 times normal in one patient; both recovered and no mention of jaundice).
Johnson S, Baraboutis JG. (2000). Adverse effects associated with use of nevirapine in HIV postexposure prophylaxis for 2 health care workers. JAMA. (33 year old nurse given lamivudine, zidovudine and nevirapine after needlestick exposure to HIV developed nausea 8 days later with fever, adenopathy and rash, with response to corticosteroids, but relapse after stopping [ALT 215 U/L], responding to second course of prednisone).
Sha BE, Proia LA, Kessler HA. (2000). Adverse effects associated with use of nevirapine in HIV postexposure prophylaxis for 2 health care workers. JAMA. (43 year old phlebotomist given zidovudine, lamivudine and nevirapine for needlestick exposure to HIV developed liver test abnormalities at day 20 [bilirubin 1.3 mg/dL, ALT 1080 U/L and Alk P 150 U/L], progressing to hepatic failure, coma and liver transplantation at day 35).
Piroth L, Grappin M, Sgro C, Buisson M, Duong M, Chavanet P. (2000). Recurrent NNRTI-induced hepatotoxicity in an HIV-HCV-coinfected patient. Ann Pharmacother. (31 year old woman with HIV-HCV coinfection developed enzyme elevations [ALT 772 U/L, GGT 1537 U/L] 5 weeks after starting nevirapine, resolving within 4 weeks of stopping, but recurring within 2 weeks of starting efavirenz [ALT 551 U/L, GT 2800 U/L], ultimately resolving within 2 months of stopping both; no mention of bilirubin or symptoms).
Sissoko D, Ajana F, de la Tribonniere X, Baclet V, Mouton Y. (2000). Manifestations cutanees, hepatiques et hematologiques liees a la nevirapine: DRESS syndrome?. Presse Med. (2 women and 1 man, ages 35 to 45 years, developed rash, fever and liver injury 3-5 weeks after starting nevirapine for HIV infection [bilirubin 1.5 and 1.4 mg/dL, ALT 5,100, 1,225 and 172 U/L, Alk P 145, 416 and 220 U/L, eosinophilia in all], resolving rapidly and completely in all with corticosteroid therapy).
Palacios R, Santos J, González M, Márquez M. (2000). Med Clin(Barc). (Among 163 patients with HIV infection started on nevirapine between 1997 and 1999, 5 developed clinically significant hepatitis after 21-24 days in 4 and after 85 days in 1 [bilirubin 2.5-17 mg/dL, ALT 146-854 U/L, Alk P 167-388 U/L], all resolving within 4 weeks of stopping).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% during antiretroviral treatment; factors associated with ALT elevations included full dose ritonavir therapy and coinfection with either HCV or HBV).
Velasco M, Guijarro C. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C which may be misdiagnosed as hepatotoxicity).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Elevated liver enzymes following initiation of antiretroviral therapy. JAMA. (Reply to Velasco and Guijarro pointing at that the majority of the ALT elevations described could not be attributed to immune reconstitution).
Puoti M, Gargiulo F, Roldan EQ, Chiodera A, Palvarini L, Spinetti A, Zaltron S, et al. (2000). Liver damage and kinetics of hepatitis C virus and human immunodeficiency virus replication during the early phases of combination antiretroviral treatment. J Infect Dis. (Monitoring viral levels during initiation of antiretroviral therapy with either nevirapine or indinavir combined with lamivudine and stavudine in 12 patients with HIV-HCV coinfection found slight rise in HCV RNA levels during weeks 1-3 of therapy, with no consistent change in ALT).
Clarke S, Harrington P, Barry M, Mulcahy F. (2000). The tolerability of efavirenz after nevirapine-related adverse events. Clin Infect Dis. (Among 8 patients stopping nevirapine because of toxicity including 3 with ALT elevations [>5 times ULN], none developed liver toxicity and only one had any symptoms [facial edema] after switching to efavirenz).
Clarke S, Harrington P, Condon C, Kelleher D, Smith OP, Mulcahy F. (2000). Late onset hepatitis and prolonged deterioration in hepatic function associated with nevirapine therapy. Int J STD AIDS. (49 year old man developed fatigue and jaundice [without fever or rash] 5 months after starting nevirapine, stavudine and didanosine for HIV infection [bilirubin 7.6 rising to 30.4 mg/dL, AST 544 U/L, Alk P 133 U/L], resolving within a few months of stopping).
García Fernández D, García-Patos Briones V, Mollet Sánchez J, Castells Rodellas A. (2000). Rev Clin Esp. (35 year old man with HIV-HCV coinfection developed severe rash, fever and eosinophilia 1 month after starting nevirapine, didanosine and stavudine [bilirubin normal, ALT 143 U/L, Alk P 274 U/L], resolving on stopping and recurrence of rash with rechallenge).
Soriano V, Dona C, Barreiro P, Gonzalez-Lahoz J. (2000). Is there cross-toxicity between nevirapine and efavirenz in subjects developing rash. AIDS. (Retrospective review, only 1 of 8 patients with rash on nevirapine developed rash on efavirenz; no mention of hepatic cross reactions).
Centers for Disease Control and Prevention (CDC). (2001). Serious adverse events attributed to nevirapine regimens for postexposure prophylaxis after HIV exposures–worldwide, 1997-2000. MMWR Morb Mortal Wkly Rep. (After two reports of acute liver failure in patients receiving nevirapine for prophylaxis against HIV exposures, CDC reviewed serious adverse event reports of nevirapine prophylaxis between 1997-2000; 22 events were identified, including 12 cases of hepatotoxicity, average latency of 3 weeks, bilirubin 2.0 to 33.7 mg/dL, ALT 182 to 2790 U/L).
Bundow D, Rosoff L, Aboulafia DM. (2001). Optimal treatment of nevirapine-associated hepatotoxicity remains uncertain. AIDS Read. (Two men, ages 39 and 33 years, developed fever, rash and eosinophilia 4 and 2 weeks after starting nevirapine [bilirubin 7.6 and 3.0 mg/dL, ALT 171 and 354 U/L, Alk P 360 and 397 U/L], resolving without corticosteroid therapy in 4-6 weeks).
Piliero PJ, Purdy B. (2001). Nevirapine-induced hepatitis: a case series and review of the literature. AIDS Read. (2 women and 2 men with HIV infection, ages 39 to 53 years, developed liver injury 2-11 weeks after starting nevirapine therapy [peak bilirubin 3.5, 10.9, 8.6 and 21.1 mg/dL, AST 268, 505, 1450 and 160 U/L, Alk P 888, 401, 238 and 150 U/L]; one with HCV coinfection died of hepatic failure, the others recovered upon stopping).
Prakash M, Poreddy V, Tiyyagura L, Bonacini M. (2001). Jaundice and hepatocellular damage associated with nevirapine therapy. Am J Gastroenterol. (Four men, ages 27 to 49 years, developed rash, fever and jaundice 4-6 weeks after starting nevirapine for HIV infection [bilirubin 8.2-17.8 mg/dL, ALT 288-3493 U/L, Alk P 258-851 U/L], resolving within 5-10 weeks of stopping).
Benn PD, Mercey DE, Brink N, Scott G, Williams IG. (2001). Prophylaxis with a nevirapine-containing triple regimen after exposure to HIV-1. Lancet. (Among 41 persons with needlestick or sexual exposure to HIV who were given nevirapine prophylaxis, 5 had ALT elevations above 5 times the ULN, all resolved, evidently none with jaundice).
Martínez E, Blanco JL, Arnaiz JA, Pérez-Cuevas JB, Mocroft A, Cruceta A, Marcos MA, et al. (2001). Hepatotoxicity in HIV-1-infected patients receiving nevirapine-containing antiretroviral therapy. AIDS. (Among 610 patients starting nevirapine, 10.8% developed ALT >3 times ULN and 1.1% developed symptoms [most were HCV positive as well], but all were reversible on stopping).
Claudio GA, Martin AF, de Dios Perrino S, Velasco AA. (2001). DRESS syndrome associated with nevirapine therapy. Arch Intern Med. (31 year old man with HIV-HCV coinfection developed rash 7 days after starting nevirapine, resolving when stopping and recurring 3 days after restarting with fever [bilirubin 12.7 mg/dL, ALT 224 U/L, Alk P 501 U/L, 30% eosinophils], resolving rapidly on stopping: Case 3).
Núñez M, Lana R, Mendoza JL, Martín-Carbonero L, Soriano V. (2001). Risk factors for severe hepatic injury after introduction of highly active antiretroviral therapy. J Acquir Immune Defic Syndr. (Retrospective review of 222 patients started on highly active antiretroviral therapy, 125 with nonnucleoside reverse transcriptase inhibitors; 31% had ALT elevation [9% >5 times ULN], risk factors were HCV infection, alcohol use and older age; transient in all except HCV infected).
Benhamou Y, Di Martino V, Bochet M, Colombet G, Thibault V, Liou A, Katlama C, Poynard T, Multivir C. (2001). Group. Factors affecting liver fibrosis in human immunodeficiency virus-and hepatitis C virus-coinfected patients: impact of protease inhibitor therapy. Hepatology. (Cross sectional study of 172 patients with HIV-HCV coinfection undergoing liver biopsy; those on protease inhibitors were less likely to have cirrhosis [6.3% vs 18.5%] and estimated 25 year cirrhosis rates were 9% vs 27%; other factors associated with fibrosis were excessive alcohol use, low CD4 counts and age of acquiring HCV).
Reisler K. (2001). High hepatotoxicity rate seen among HAART patients. AIDS Alert. (News report on abstract: study of 10,011 patients in 21 clinical trials with HIV infection, showing that ALT elevations >5 times normal occur in 6.2% of highly active antiretroviral therapy treated patients; 10.8% with efavirenz, 8.9% with nevirapine and 6% with delavirdine in short term studies).
González de Requena D, Núñez M, Jiménez-Nácher I, Soriano V. (2002). Liver toxicity caused by nevirapine. AIDS. (Case control study in 70 patients with HIV infection on nevirapine; higher plasma levels were found in those with ALT elevations [6.25 vs 5.2 µg/mL], particularly in patients with HIV-HCV co-infection).
Bonnet F, Lawson-Ayayi S, Thiébaut R, Ramanampamonjy R, Lacoste D, Bernard N, Malvy D, et al. (2002). French Aquitaine Cohort. Groupe d'Epidémiologie Clinique du SIDA en Aquitaine (GECSA). A cohort study of nevirapine tolerance in clinical practice: French Aquitaine Cohort, 1997-1999. Clin Infect Dis. (Retrospective study in 137 patients in routine clinical practice, 33% had side effects and 21% stopped nevirapine; 20% with rash, 1 Stevens Johnson syndrome; ALT >100 U/L in 43% of HCV or HBV coinfected and 9% without either).
Macías J, Melguizo I, Fernández-Rivera FJ, García-García A, Mira JA, Ramos AJ, Rivera JM, Pineda JA. (2002). Mortality due to liver failure and impact on survival of hepatitis virus infections in HIV-infected patients receiving potent antiretroviral therapy. Eur J Clin Microbiol Infect Dis. (While mortality due to AIDS declined from 4.5 to 1.8/100 person years with introduction of highly active antiretroviral therapy, mortality from liver disease increased from 0.3 to 0.5/100 person years).
De Maat MM, Mathôt RA, Veldkamp AI, Huitma AD, Mulder JW, Meenhorst PL, Van Gorp EC, Carlier H, Beijnen JH. (2002). Hepatotoxicity following nevirapine-containing regimens in HIV-1-infected individuals. Pharmacol Res. (Retrospective analysis of 174 patients receiving nevirapine based antiretroviral therapy; only 3.4% had ALT or AST elevations >5 times ULN, no correlation with plasma levels; risk factors were HBV coinfection and use of protease inhibitors).
Clark SJ, Creighton S, Portmann B, Taylor C, Wendon JA, Cramp ME. (2002). Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol. (6 patients with HIV infection who developed acute liver failure on antiretroviral therapy, including stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delavirdine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 with signs of hypersensitivity; two with hepatitis B; 5 died, autopsies showing massive necrosis; one with massive steatosis; likely multiple causes).
Johnson S, Chan J, Bennett CL. (2002). Hepatotoxicity after prophylaxis with a nevirapine-containing antiretroviral regimen. Ann Intern Med. (Among 174 health care workers receiving prophylaxis after accidental exposure to HIV, 8 received nevirapine containing regimens, 5 had severe hepatotoxicity, and one required liver transplantation).
Palmon R, Koo BC, Shoultz DA, Dieterich DT. (2002). Lack of hepatotoxicity associated with nonnucleoside reverse transcriptase inhibitors. J Acquir Immune Defic Syndr. (Retrospective analysis of 272 HIV-positive patients seen in an New York City practice; ALT elevations above 5 times ULN occurred in only 1.1% regardless of type of nonnucleoside reverse transcriptase inhibitor used or presence of coinfection with HBV or HCV).
Gökengin D, Yamazhan T. (2002). Hepatic adverse events during highly active antiretroviral therapy containing nevirapine: a case report. Ann Clin Microbiol Antimicrob. (39 year old man with HIV infection developed fever and malaise one month after starting nevirapine, zidovudine and lamivudine [bilirubin 1.7 mg/dL, ALT 1558 U/L, Alk P 577 U/L], resolving within 2 weeks of stopping; lamivudine and zidovudine were restarted).
Dodi F, Alessandrini A, Camera M, Lorenzo G, Morandi N, Pagano G. (2002). Stevens-Johnson syndrome in HIV patients treated with nevirapine: two case reports. AIDS. (35 and 37 year old men with HIV infection developed generalized rash and oral erosions or palmar involvement 20 and 29 days after starting nevirapine, both requiring corticosteroids and having slow recovery; ALT levels were elevated in one patient who also had HCV infection).
Dybul M, Fauci AS, Bartlett JG, Kaplan JE, Pau AK, Panel on Clinical Practices for the Treatment of HIV. (2002). Guidelines for using antiretroviral agents among HIV-infected adults and adolescents. Recommendations of the Panel on Clinical Practices for Treatment of HIV. MMWR Recomm Rep. (Recommendations on use of antiretroviral agents for HIV infection including indications, efficacy, need for monitoring and side effects including hepatotoxicity).
Sulkowski MS, Thomas DL, Mehta SH, Chaisson RE, Moore RD. (2002). Hepatotoxicity associated with nevirapine or efavirenz-containing antiretroviral therapy: role of hepatitis C and B infections. Hepatology. (Prospective analysis of 568 patients, ALT levels >5 times ULN occurred in 16% on nevirapine and 8% on efavirenz, only 1/3rd in first 12 weeks, usually associated with HBV or HCV coinfection [69%] or concurrent protease inhibitor use [82%]; no recurrence on switching from one to the other).
Martín-Carbonero L, Núñez M, Ríos P, Pérez-Olmeda M, González-Lahoz J, Soriano V. (2002). Liver injury after beginning antiretroviral therapy in HIV/hepatitis C virus co-infected patients is not related to immune reconstitution. AIDS. (Among 42 patients with HIV-HCV coinfection who were started on antiretroviral therapy, 30 [72%] developed ALT elevations which were above 5 times ULN in 6 [14%], but there was no association of these elevations with decreases in HIV RNA levels or increases in CD4 counts of HCV RNA levels).
Pulido F, Torralba M. (2002). NNRTI hepatotoxicity: efavirenz versus nevirapine. J HIV Ther. (Review of hepatotoxicity of all antiretrovirals with focus on nonnucleoside reverse transcriptase inhibitors).
Wit FW, Weverling GJ, Weel J, Jurriaans S, Lange JM. (2002). Incidence of and risk factors for severe hepatotoxicity associated with antiretroviral combination therapy. J Infect Dis. (Retrospective analysis found 6.3% incidence of liver enzyme elevations >5 times ULN among 560 Dutch patients on highly active antiretroviral therapy, 71% had either HBV or HCV coinfection; risk factors included recent introduction of nevirapine or high dose ritonavir or stopping lamivudine).
Kontorinis N, Dieterich DT. (2003). Toxicity of non-nucleoside analogue reverse transcriptase inhibitors. Semin Liver Dis. (Review of hepatotoxicity of nonnucleoside reverse transcriptase inhibitors; rate of ALT elevations >5 times ULN is ~6% at 6 weeks, but thereafter is similar in nevirapine and placebo recipients raising questions regarding the causality of late elevations; ALT elevations occurred in >30% of patients on nevirapine, but lower rate of severe elevations, estimated to be 8.9% in metaanalysis of 21 studies, compared to 10.8% with efavirenz and 3.6% with delavirdine).
Knudtson E, Para M, Boswell H, Fan-Havard P. (2003). Drug rash with eosinophilia and systemic symptoms syndrome and renal toxicity with a nevirapine-containing regimen in a pregnant patient with human immunodeficiency virus. Obstet Gynecol. (26 year old pregnant woman with CD4 count of 614 developed rash and fever 6 weeks after starting lamivudine, zidovudine and nevirapine [9.6% eosinophilia, bilirubin 12 mg/dL, ALT 235 U/L, Alk P 257 U/L, INR 2.4], who worsened despite stopping nevirapine and receiving corticosteroids; had emergency Caesarian with subsequent recovery: Case 2).
Wetterwald E, Le Cleach L, Michel C, David F, Revuz J. (1999). Nevirapine-induced overlap Stevens-Johnson syndrome/toxic epidermal necrolysis. Br J Dermatol. (35 and 40 year old men with HIV infection developed rash, mouth ulcers and fever 13 and 25 days after starting nevirapine with changes of both Stevens-Johnson syndrome [mucosal involvement and fever] and toxic epidermal necrolysis [skin detachment], no mention of hepatotoxicity; both recovered in 2 and 4 weeks).
Martinez-Sierra C, Arizcorreta A, Diaz F, Roldan R, Martin-Herrera L, Perez-Guzman E, Giron-Gonzalez JA. (2003). Progression of chronic hepatitis C to liver fibrosis and cirrhosis in patients coinfected with hepatitis C virus and human immunodeficiency virus. Clin Infect Dis. (Comparison of 41 patients with HIV-HCV coinfection and 147 with HCV infection alone for clinical features; higher HCV RNA levels and more advanced fibrosis were found in HIV infected).
Mohsen AH, Easterbrook PJ, Taylor C, Portmann B, Kulaegaram R, Murah S, Wiselka M, et al. (2003). Impact of human immunodeficiency virus(HIV) infection on the progression of liver fibrosis in hepatitis C virus infected patients. Gut. (Estimated rate of fibrosis progression in cross sectional study of 153 HCV-infected and 55 HCV-HIV coinfected patients undergoing liver biopsy; HIV was associated with more rapid progression as was older age and higher ALT levels).
Núñez M, González-Requena D, González-Lahoz J, Soriano V. (2003). Short communication: interactions between nevirapine plasma levels, chronic hepatitis C, and the development of liver toxicity in HIV-infected patients. AIDS Res Hum Retroviruses. (Case controlled study of 70 patients treated with nevirapine for HIV infection; nevirapine plasma levels were the same in HIV-HCV co-infected as in HIV-mono-infected patients: 5.8 vs 6.1 µg/mL: see Gonzalez de Requena 2002).
Qurishi N, Kreuzberg C, Luchters G, Effenberger W, Kupfer B, Sauerbruch T, Rockstroh JK, et al. (2003). Effect of antiretroviral therapy on liver-related mortality in patients with HIV hepatitis C virus coinfection. Lancet. (In a cohort of 285 patients with HIV infection, both overall and liver related mortality decreased [1.70 to 0.70 to 0.45 per 100 person years] with introduction of nucleoside analogues and then highly active antiretroviral therapy; 18 cases of severe hepatotoxicity [14% of treated], but none were fatal).
Tural C, Fuster D, Tor J, Ojanguren I, Sirera G, Ballesteros A, Lasanta JAJ, et al. (2003). Time on antiretroviral therapy is a protective factor for liver fibrosis in HIV and hepatitis C virus(HCV) co-infected patients. J Viral Hepat. (Cross sectional analysis of 126 patients with HIV-HCV coinfection undergoing liver biopsy identified time on antiretroviral therapy as predictive of lesser degrees of fibrosis).
de Maat MM, ter Heine R, van Gorp EC, Mulder JW, Mairuhu AT, Beijnen JH. (2003). Case series of acute hepatitis in a non-selected group of HIV-infected patients on nevirapine-containing antiretroviral treatment. AIDS. (Among 306 patients starting a nevirapine-containing regimen for HIV infection, 8 developed acute hepatitis [2.6%] after 8-31 days [bilirubin 0.5-5.8 mg/mL, ALT 150-596 U/L, Alk P 67-789 U/L], all resolving within 2-7 weeks of stopping).
Dore G. (2003). Antiretroviral therapy-related hepatotoxicity: predictors and clinical management. J HIV Ther. (Review with suggested algorithm for management of ALT elevations on antiretroviral therapy).
Weissbrich B, Langmann P, Schubert J, Jassoy C, Klinker H. (2003). Resolution of HCV infection in a HIV-infected patient under HAART after several hepatitis flare-ups. Eur J Med Res. (43 year old man with HIV and severe hepatitis C became HIV and HCV RNA negative after complications of cirrhosis and while on long term nevirapine and indinavir therapy).
Law WP, Dore GJ, Duncombe CJ, Mahanontharit A, Boyd MA, Ruxrungtham K, Lange JM, et al. (2003). Risk of severe hepatotoxicity associated with antiretroviral therapy in the HIV-NAT Cohort, Thailand, 1996-2001. AIDS. (Among 692 patients in 8 controlled trials in Thailand, rate of ALT elevations above 5 times ULN was 6.1/100 patient years overall; in multivariate analysis, risk factors were HBV [Relative risk=3.9], HCV [3.0], and use of nonnucleoside reverse transcriptase inhibitors [6.8], rate with nevirapine [18.6/100 person years] higher than efavirenz [2.4/100 person years]).
Ena J, Amador C, Benito C, Fenoll V, Pasquau F. (2003). Risk and determinants of developing severe liver toxicity during therapy with nevirapine-and efavirenz-containing regimens in HIV-infected patients. Int J STD AIDS. (Retrospective review of 136 patients treated with regimens including nonnucleoside reverse transcriptase inhibitors, 48% had ALT elevations which were >5 times ULN in 20%; risk factors were alcohol use, HCV infection and 4 drug regimens; 3 of 17 patients with ALT elevations on nevirapine redeveloped ALT elevations on restarting; 2 patient had jaundice, but had HCV coinfection and were exposed to other hepatotoxins).
Martín-Carbonero L, Núñez M, González-Lahoz J, Soriano V. (2003). Incidence of liver injury after beginning antiretroviral therapy with efavirenz or nevirapine. HIV Clin Trials. (Retrospective analysis of risk factors for liver toxicity in 162 patients on nevirapine [12%] and 136 on efavirenz [4%], average onset at 5 months, risk factors were nevirapine [relative risk=3.1], HCV coinfection [4.7], alcohol abuse [4.5] and female gender [2.3]).
Jackson JB, Barnett S, Piwowar-Manning E, Apuzzo L, Raines C, Hendrix C, Hamzeh F, et al. (2003). A phase I/II study of nevirapine for pre-exposure prophylaxis of HIV-1 transmission in uninfected subjects at high risk. AIDS. (Trial comparing weekly, twice weekly vs every other day nevirapine for 4 weeks in 33 subjects acutely exposed to HIV infection, 3 developed ALT elevations above 5 times ULN, but no clinically apparent jaundice).
Ofotokun I, Pomeroy C. (2003). Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men).
Ogedegbe AO, Sulkowski MS. (2003). Antiretroviral-associated liver injury. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommended monitoring at 4 weeks and then every 12 weeks, monitoring more closely if ALT levels are elevated and stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present).
Martín-Carbonero L, Benhamou Y, Puoti M, Berenguer J, Mallolas J, Quereda C, Arizcorreta A, et al. (2004). Incidence and predictors of severe liver fibrosis in human immunodeficiency virus-infected patients with chronic hepatitis C: a European collaborative study. Clin Infect Dis. (Analysis from 10 European centers of fibrosis on liver biopsies from 914 HIV-HCV coinfected patients; 13% had cirrhosis; predictors of severe fibrosis were older age [Odds Ratio=2.95], excessive alcohol use [1.6], and low CD4 counts [1.4], but not use of antiretroviral therapy).
Stern JO, Robinson PA, Love J, Lanes S, Imperiale MS, Mayers DL. (2003). A comprehensive hepatic safety analysis of nevirapine in different populations of HIV infected patients. J Acquir Immune Defic Syndr. (Analysis of data from 17 randomized controlled trials of nevirapine done between 1991 and 2001, ALT >5 times ULN in 10%, 2/3rds were asymptomatic; risk factors were elevated baseline ALT levels, HBV or HCV coinfection, and higher baseline CD4 counts; 4 of 2545 patients died of liver failure in noncomparative trials and 3 among 5302 patients in cohort studies ~1/1000).
Baylor MS, Johann-Liang R. (2004). Hepatotoxicity associated with nevirapine use. J Acquir Immune Defic Syndr. (Letter in response to Stern et al. from members of the FDA whose analyses identified 285 patients [11%] with hepatic adverse events due to nevirapine; rash associated events in 2.7%, symptomatic hepatitis in 2.7%; associated with higher pretreatment CD4 counts).
Negredo E, Moltó J, Muñoz-Moreno JA, Pedrol E, Ribera E, Viciana P, Galindos MJ, et al. (2004). Safety and efficacy of once-daily didanosine, tenofovir and nevirapine as a simplification antiretroviral approach. Antivir Ther. (Controlled trial of switching to once daily highly active antiretroviral regimen that included nevirapine in 169 patients, adverse events requiring discontinuation higher with daily regimen [14% vs 4%], including 5 cases of hepatotoxicity not otherwise characterized).
Dieterich DT, Robinson PA, Love J, Stern JO. (2004). Drug-induced liver injury associated with the use of nonnucleoside reverse-transcriptase inhibitors. Clin Infect Dis. (Extensive review of hepatotoxicity of nonnucleoside reverse transcriptase inhibitors; in 17 controlled trials of nevirapine, 10% of patients developed ALT or AST elevations >5 times ULN and 5% had symptomatic hepatic event, 2.2% with rash).
Manfredi R, Calza L, Chiodo F. (2004). Efavirenz versus nevirapine in current clinical practice: a prospective, open-label observational study. J Acquir Immune Defic Syndr. (Comparison of 287 patients on efavirenz vs 258 on nevirapine in practice situation; similar efficacy against HIV but higher rate of ALT abnormalities with nevirapine [52% vs 18%] and discontinuation because of liver toxicity [3.5% vs 0%]).
Becker S. (2004). Liver toxicity in epidemiological cohorts. Clin Infect Dis. (Analysis of four large cohort studies of 5133 patients found hepatotoxicity rates similar with all antiretrovirals; major risk factor being coinfection with HBV or HCV. Nevirapine and ritonavir were associated with increased risk of hepatotoxicity in first 12 weeks).
Patel SM, Johnson S, Belknap SM, Chan J, Sha BE, Bennett C. (2004). Serious adverse cutaneous and hepatic toxicities associated with nevirapine use by non-HIV-infected individuals. J Acquir Immune Defic Syndr. (Analysis of MedWatch system and published results found 12 instances of severe rash [3 Stevens-Johnson syndrome] in non-HIV infected persons receiving nevirapine as prophylaxis against acute HIV exposure, arising after 7-12 days, 6 with fever; 30 instances of liver injury, after average of 20 days, one fulminant).
Rey D, Partisani M, Hess-Kempf G, Krantz V, Priester M, Cheneau C, Bernard-Henry C, et al. (2004). Tolerance of a short course of nevirapine, associated with 2 nucleoside analogues, in postexposure prophylaxis of HIV. J Acquir Immune Defic Syndr. (Results of using nevirapine for 4 days and two nucleoside analogues for 1 month as prophylaxis against possible HIV exposure in 120 patients: 2.8% had transient ALT elevations, but no clinically apparent liver injury and no transmission).
Pujari SN, Patel AK, Naik E, Patel KK, Dravid A, Patel JK, Mane AA, et al. (2004). Effectiveness of generic fixed-dose combinations of highly active antiretroviral therapy for treatment of HIV infection in India. J Acquir Immune Defic Syndr. (Analysis of 1291 patients started on nevirapine based combination regimens in India; rash in 6.6% and hepatitis in 3.2%, but no deaths from liver injury except 4 with lactic acidosis on stavudine).
Meraviglia P, Schiavini M, Castagna A, Viganò P, Bini T, Landonio S, Danise A, et al. (2004). Lopinavir/ritonavir treatment in HIV antiretroviral-experienced patients: evaluation of risk factors for liver enzyme elevation. HIV Med. (Among 782 patients on lopinavir/ritonavir for mean of one year, 9.1% had serum enzyme elevations largely in HBV or HCV coinfected patients [16% vs 3% without coinfection]; no association with nevirapine use; 13 stopped therapy because of liver toxicity).
Hitti J, Frenkel LM, Stek AM, Nachman SA, Baker D, Gonzalez-Garcia A, Provisor A, et al., PACTG 1022 Study Team. (2004). Maternal toxicity with continuous nevirapine in pregnancy: results from PACTG 1022. J Acquir Immune Defic Syndr. (Controlled trial of nelfinavir vs nevirapine combined with lamivudine and zidovudine in HIV-positive pregnant women; 5 women stopped nevirapine, 1 for Stevens-Johnson syndrome and 4 for hepatotoxicity including one death from hepatic failure; 1 stopped nelfinavir for clinical hepatitis).
Almond LM, Boffito M, Hoggard PG, Bonora S, Raiteri R, Reynolds HE, Garazzino S, et al. (2004). The relationship between nevirapine plasma concentrations and abnormal liver function tests. AIDS Res Hum Retroviruses. (Among 85 patients on a nevirapine based regimen, there was no association between ALT elevations and plasma nevirapine levels; slightly higher levels were present in HBV and HCV coinfected than HIV monoinfected patients).
Claes P, Wintzen M, Allard S, Simons P, De Coninck A, Lacor P. (2004). Nevirapine-induced toxic epidermal necrolysis and toxic hepatitis treated successfully with a combination of intravenous immunoglobulins and N-acetylcysteine. Eur J Intern Med. (39 year old man developed oral ulcers within 2 weeks of starting nevirapine, progressing to Stevens-Johnson syndrome and severe hepatitis, with rapid improvement after IVIG and N-acetylcysteine therapy; few details provided).
Dailly E, Billaud E, Reliquet V, Breurec S, Perré P, Léautez S, Jolliet P, et al. (2004). No relationship between high nevirapine plasma concentration and hepatotoxicity in HIV-1-infected patients naive of antiretroviral treatment or switched from protease inhibitors. Eur J Clin Pharmacol. (Among 77 patients with HIV infection starting nevirapine, elevated plasma levels did not correlate with serum AST elevations).
Macías J, Castellano V, Merchante N, Palacios RB, Mira JA, Sáez C, García-García JA, et al. (2004). Effect of antiretroviral drugs on liver fibrosis in HIV-infected patients with chronic hepatitis C: harmful impact of nevirapine. AIDS. (Cross sectional analysis of factors associated with hepatic fibrosis among 152 of 559 patients with HIV-HCV coinfection undergoing liver biopsy; advanced fibrosis was more common with higher age of infection, use of protease inhibitors and nevirapine based therapy).
Rodríguez Guardado A, Maradona Hidalgo JA, Asensi Alvarez V, Cartón Sánchez JA. (2004). Med Clin (Barc). (Retrospective analysis of 57 patients treated with nevirapine [and two nucleosides]; ALT elevations >100 U/L or twice baseline in 68% of 31 HCV-infected and 8% of 26 noninfected patients; no significant change in HCV RNA levels on therapy).
Te HS. (2004). Cholestasis in HIV-infected patients. Clin Liver Dis. (Review of causes of cholestasis in HIV-infected patients including antiretrovirals).
de Maat MM, Beijnen JH, Schellens JH, Mulder JW. (2005). Chronic hepatotoxicity after long-term antiretroviral treatment including nevirapine. J Infect. (Case report of patient without HBV or HCV infection on nevirapine with mild ALT elevations that appeared to correlate with nevirapine levels and decreased with dose modification).
Sanne I, Mommeja-Marin H, Hinkle J, Bartlett JA, Lederman MM, Maartens G, Wakeford C, et al. (2005). Severe hepatotoxicity associated with nevirapine use in HIV-infected subjects. J Infect Dis. (In a prospective study, ALT elevations >5 times normal occurred in 17% [66/385] of nevirapine vs 0% [0/83] of efavirenz treated patients, usually in first 12 weeks, most had symptoms including rash, nausea and jaundice; two cases of acute liver failure and death on nevirapine).
Pineda JA, Macías J. (2005). Progression of liver fibrosis in patients coinfected with hepatitis C virus and human immunodeficiency virus undergoing antiretroviral therapy. J Antimicrob Chemother. (Review of evidence that HAART therapy has an effect on progression of fibrosis in chronic hepatitis C).
Aranzabal L, Casado JL, Moya J, Quereda C, Diz S, Moreno A, Moreno L, et al. (2005). Influence of liver fibrosis on highly active antiretroviral therapy-associated hepatotoxicity in patients with HIV and hepatitis C virus coinfection. Clin Infect Dis. (Among 107 patients with HIV-HCV coinfection and pretreatment liver biopsy; ALT elevations of >5 times ULN [or 3.5 times baseline] occurred in 38% with advanced fibrosis and 15% without. Higher rates of ALT elevations with nevirapine and efavirenz [13%] found only in those with advanced fibrosis).
Martin AM, Nolan D, James I, Cameron P, Keller J, Moore C, Phillips E, et al. (2005). Predisposition to nevirapine hypersensitivity associated with HLA-DRB1*0101 and abrogated by low CD4 T-cell counts. AIDS. (Among 235 patients on nevirapine, 26 [11%] developed rash, fever or liver abnormalities within 6 weeks; HLA-DRB1*0101 positivity was present in 17% with rash vs 4% without, with significant interactions with CD4 counts).
Joy S, Poi M, Hughes L, Brady MT, Koletar SL, Para MF, Fan-Havard P. (2005). Third-trimester maternal toxicity with nevirapine use in pregnancy. Obstet Gynecol. (Among 23 pregnant women with HIV given nevirapine, 3 [13%] developed liver injury, 2 with rash, eosinophilia and ALT elevations, one with asymptomatic ALT elevation [ALT 235, 295 and 241 U/L]; all 3 had baseline CD4 counts of >250/µL).
Rotger M, Colombo S, Furrer H, Bleiber G, Buclin T, Lee BL, Keiser O, et al., Swiss HIV Cohort Study. (2005). Influence of CYP2B6 polymorphism on plasma and intracellular concentrations and toxicity of efavirenz and nevirapine in HIV-infected patients. Pharmacogenet Genomics. (Analysis of polymorphisms of CYP 2B6, the major hepatic enzyme responsible for efavirenz and nevirapine metabolism; G516T was associated with higher drug levels for both agents and higher tissue levels correlated with greater neuropsychiatric side effects).
Abrescia N, D’Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. (2005). Hepatotoxicity of antiretroviral drugs. Curr Pharm Des. (Review of hepatotoxicity of antiretrovirals; major syndrome with nonnucleoside reverse transcriptase inhibitors is hypersensitivity).
Núñez M, Soriano V. (2005). Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. Drug Saf. (Review of liver toxicity of antiretrovirals).
Fields KS, Petersen MJ, Chiao E, Tristani-Firouzi P. (2005). Case reports: treatment of nevirapine-associated dress syndrome with intravenous immune globulin(IVIG). J Drugs Dermatol. (Onset of rash, fever, oral ulcers and adenopathy after 4 weeks of nevirapine therapy with jaundice [bilirubin 9.8 mg/dL, ALT 362 U/L, Alk P 283 U/L, eosinophils 12%], recovery in 6 weeks perhaps with help of intravenous immune globulin infusions).
Kappelhoff BS, van Leth F, Robinson PA, MacGregor TR, Baraldi E, Montella F, Uip DE, et al. (2005). 2NN Study Group. Are adverse events of nevirapine and efavirenz related to plasma concentrations?. Antivir Ther. (Among 1077 HIV positive patients started on treatment, no association was found between adverse events and plasma levels or pharmacokinetics of nevirapine or efavirenz).
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al., EPOKA-MASTER Study Group. (2005). Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, the risk of ALT elevations above 5 times ULN was 17.1/100 patient years in treatment-naïve and 8.2 in treatment-experienced group; risk factors being higher baseline ALT levels and use of nonnucleoside reverse transcriptase inhibitors).
Zhou J, Phanupak P, Kiertiburanakul S, Ditangco R, Kamarulzaman A, Pujary S. (2006). TREAT Asia HIV Observational Database. Highly active antiretroviral treatment containing efavirenz or nevirapine and related toxicity in the TREAT Asia HIV Observational Database. J Acquir Immune Defic Syndr. (Analysis of 735 HIV-positive patients starting efavirenz and 813 starting nevirapine containing regimens; 12 patients in both groups developed ALT levels >5 times ULN, but monitoring was irregular; no deaths from liver disease occurred and no racial differences in rates of ALT elevations were found; HCV coinfection was a risk factor).
Buyse S, Vibert E, Sebagh M, Antonini T, Ichai P, Castaing D, Samuel D, et al. (2006). Liver transplantation for fulminant hepatitis related to nevirapine therapy. Liver Transpl. (38 year old woman with HIV infection developed acute liver failure 6 weeks after starting nevirapine, zidovudine and lamivudine [bilirubin 11.2 mg/dL, ALT 12578 U/L, GGT 340 U/L], undergoing liver transplantation and later tolerating efavirenz without recurrence: Case 1).
Haas DW, Bartlett JA, Andersen JW, Sanne I, Wilkinson GR, Hinkle J, Rousseau F, et al., Adult AIDS Clinical Trials Group. (2006). Pharmacogenetics of nevirapine-associated hepatotoxicity: an Adult AIDS Clinical Trials Group collaboration. Clin Infect Dis. (A polymorphism of the MDR gene [p-glycoprotein] was associated with lower rate of hepatotoxicity attributed to nevirapine in a controlled trial conducted in South Africa: 10.6% of cases vs 19.4% of controls had MDR1 3435C→T, believed to have an effect on the transporter function of MDR1; no linkage to CYP polymorphisms found).
Ritchie MD, Haas DW, Motsinger AA, Donahue JP, Erdem H, Raffanti S, Rebeiro P, et al. (2006). Drug transporter and metabolizing enzyme gene variants and nonnucleoside reverse-transcriptase inhibitor hepatotoxicity. Clin Infect Dis. (Case control study of 9 nevirapine and 4 efavirenz recipients who developed ALT >5 times ULN on therapy vs 49 controls; found weak association with MDR1 [p-glycoprotein: ABCB1] polymorphism).
Maniar JK, Shah SR, Verma R, Kamath R, Gupte P, Maniar A. (2006). Nevirapine-induced fulminant hepatitis. J Assoc Physicians India. (38 year old man with HIV infection developed abdominal pain and nausea 3 weeks after starting nevirapine, zidovudine and lamivudine [bilirubin 1.4 mg/dL, ALT 1421 U/L, Alk P not given, INR 2.6], with rapid deterioration and death in 3 days).
Lyons F, Hopkins S, Kelleher B, McGeary A, Sheehan G, Geoghegan J, Bergin C, et al. (2006). Maternal hepatotoxicity with nevirapine as part of combination antiretroviral therapy in pregnancy. HIV Med. (Retrospective analysis of 123 women given antiretroviral regimen including nevirapine [usually with zidovudine and lamivudine] during pregnancy; one-third had ALT elevations, 8 developed ALT or AST levels >5 times ULN and 2 had fever, rash and hepatitis at 4 and 8 weeks subsequently dying of hepatic failure; risk factors appeared to be higher CD4 counts and black race).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003, 4690 reports of drug induced liver fatality; nevirapine was the 9th most common cause [~60 cases]).
Drummond NS, Vilar FJ, Naisbitt DJ, Hanson A, Woods A, Park BK, Pirmohamed M. (2006). Drug-specific T cells in an HIV-positive patient with nevirapine-induced hepatitis. Antivir Ther. (30 year old man with HIV infection developed nausea and jaundice without rash 4 weeks after starting nevirapine [bilirubin levels unclear, ALT ~950 U/L, Alk P ~610 U/L], resolving within 6 weeks of stopping; positive lymphocyte stimulation, but unable to clone specific T cells).
Maida I, Núñez M, Ríos MJ, Martín-Carbonero L, Sotgiu G, Toro C, Rivas P, et al. (2006). Severe liver disease associated with prolonged exposure to antiretroviral drugs. J Acquir Immune Defic Syndr. (Survey of 3200 HIV-positive patients in Spain identified 17 [0.5%] with cryptogenic chronic liver disease, 83% male, ages 27-57 years, mostly gay men with long term infection; minimal ALT, GGT, and Alk P elevations; biopsy in 5 showed nonspecific changes, elastography often abnormal; didanosine implicated in case controlled analysis, multifactorial, but some cases may have represented nodular regeneration rather than cirrhosis).
Lyons F, Hopkins S, Kelleher B, McGeary A, Sheehan G, Geoghegan J, Bergin C, et al. (2006). Maternal hepatotoxicity with nevirapine as part of combination antiretroviral therapy in pregnancy. HIV Med. (Retrospective analysis of 123 pregnant women in Dublin treated with nevirapine; 8 developed hepatotoxicity with ALT >5 times ULN; two died of fulminant hepatitis [onset after 4 and 5 weeks of nevirapine, lamivudine and zidovudine with rash followed by jaundice; bilirubin 12.5 and 5.9 mg/dL, AST 2850 and 1276 U/L], rapidly progressing to coma and death; lesser ALT elevations occurred in another 25% of patients).
João EC, Calvet GA, Menezes JA, D'Ippolito MM, Cruz ML, Salgado LA, Matos HJ. (2006). Nevirapine toxicity in a cohort of HIV-1-infected pregnant women. Am J Obstet Gynecol. (Retrospective study of 197 pregnant women in Brazil given nevirapine; enzyme elevations occurred in 5.6%, but only one case of serious liver toxicity, marked by rash and cholestatic hepatitis at 7 weeks).
Servoss JC, Kitch DW, Andersen JW, Reisler RB, Chung RT, Robbins GK. (2006). Predictors of antiretroviral-related hepatotoxicity in the adult AIDS Clinical Trial Group (1989-1999). J Acquir Immune Defic Syndr. (Analysis of factors that predict “serious hepatotoxicity” in 9% of cohort of 8851 patients with HIV infection enrolled in trials of antiretroviral therapy; factors identified included elevated baseline liver tests, HCV coinfection, and in subgroups, didanosine, nevirapine and stavudine use).
Hofman P, Nelson AM. (2006). The pathology induced by highly active antiretroviral therapy against human immunodeficiency virus: an update. Curr Med Chem. (Review of pathology of adverse effects of antiretroviral agents with examples of hepatic mitochondrial liver injury and cholestasis).
Núñez M. (2006). Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. J Hepatol. (Review of hepatotoxicity of antiretrovirals; elevations in ALT or AST above 5 times ULN occurs in 2-18% of HIV-positive patients starting therapy, more frequent with HCV or HBV coinfection; combination of protease inhibitors with low dose ritonavir does not seem to increase risk; agents with highest risk are nevirapine and the nonnucleoside reverse transcriptase inhibitors).
Kondo W, Carraro EA, Prandel E, Dias JM, Perini J, Macedo RL, Cornelsen TC, et al. (2007). Nevirapine-induced side effects in pregnant women: experience of a Brazilian university hospital. Braz J Infect Dis. (Among 133 women starting antiretroviral therapy during pregnancy, 21 [16%] developed rash and 6 [5%] ALT elevations usually within the first 7 weeks; all had CD4 counts >250/µL before therapy, none developed jaundice or Stevens-Johnson syndrome).
Forna F, Liechty CA, Solberg P, Asiimwe F, Were W, Mermin J, Behumbiize P, et al. (2007). Clinical toxicity of highly active antiretroviral therapy in a home-based AIDS care program in rural Uganda. J Acquir Immune Defic Syndr. (Among 1029 adults started on nevirapine with lamivudine and stavudine, 58 [~6%] developed rash and 5 [~.5%] developed acute hepatitis, 3 with rash; 1 death due to hypersensitivity syndrome and hepatitis arising 4 weeks after starting triple therapy with nevirapine).
Hall DB, Macgregor TR. (2007). Case-control exploration of relationships between early rash or liver toxicity and plasma concentrations of nevirapine and primary metabolites. HIV Clin Trials. (Case controlled study of plasma nevirapine and metabolite levels in 49 patients with a hypersensitivity reaction and 49 controls; no significant differences, indicating the idiosyncratic nature of this response).
Mehta U, Maartens G. (2007). Is it safe to switch between efavirenz and nevirapine in the event of toxicity?. Lancet Infect Dis. (Review; some evidence of cross sensitivity between nevirapine and efavirenz to skin rash, but none to hepatotoxicity; total of 11 patients reported in literature to have switched and none had recurrence of liver injury).
Phillips E, Gutiérrez S, Jahnke N, Yip B, Lima VD, Hogg RS, Harrigan PR, et al. (2007). Determinants of nevirapine hypersensitivity and its effect on the association between hepatitis C status and mortality in antiretroviral drug-naïve HIV-positive patients. AIDS. (Database analysis of nevirapine “hypersensitivity reaction” which occurred in 9.6% of patients and was associated with poor prognosis; no predictive factors of the reaction and unclear whether definition accurately captured all hypersensitivity reactions).
Manfredi R, Calza L. (2007). Safety issues about nevirapine administration in HIV-infected pregnant women. J Acquir Immune Defic Syndr. (Experience in managing 31 pregnant women on nevirapine, none developing clinically apparent hepatotoxicity or ALT elevations above 5 times ULN).
Natarajan U, Pym A, McDonald C, Velisetty P, Edwards SG, Hay P, Welch J, et al. (2007). Safety of nevirapine in pregnancy. HIV Med. (Retrospective study of 235 pregnant women with HIV infection in UK treated with nevirapine containing regimens; 6% developed rash and 3.4% hepatotoxicity within 6 weeks [ALT 161-807 U/L], all recovered).
Rivero A, Mira JA, Pineda JA. (2007). Liver toxicity induced by non-nucleoside reverse transcriptase inhibitors. J Antimicrob Chemother. (Review of liver toxicity of nevirapine and efavirenz; ALT elevations reported in 1-8% of efavirenz compared to 4-16% of nevirapine recipients).
Maggiolo F, Arici C, Airoldi M, Ripamonti D, Quinzan G, Gregis G, Ravasio V, et al. (2007). Reasons for discontinuation of nevirapine-containing HAART: results from an unselected population of a large clinical cohort. J Antimicrob Chemother. (Experience in use of nevirapine in 582 patients; among 286 discontinuations, hepatotoxicity was cause in only 29 [4%]; ALT elevations >5 ULN occurred in 10.2% [5.3/100 patient years]).
Jamisse L, Balkus J, Hitti J, Gloyd S, Manuel R, Osman N, Djedje M, et al. (2007). Antiretroviral-associated toxicity among HIV-1-seropositive pregnant women in Mozambique receiving nevirapine-based regimens. J Acquir Immune Defic Syndr. (Among 146 pregnant women given triple therapy with nevirapine, 11 [8%] had ALT elevations >2.5 times ULN and 4 [2.7%] above 5 times ULN [261-690 U/L] 4-10 weeks after starting, all recovered upon stopping).
Hahn JA, Maier M, Byakika-Tusiime J, Oyugi JH, Bangsberg DR. (2007). Hepatotoxicity during nevirapine-based fixed-dose combination antiretroviral therapy in Kampala, Uganda. J Int Assoc Physicians AIDS Care (Chic). (Prospective study of 97 patients starting nevirapine-based antiretroviral therapy in Uganda followed for 1-20 months; ALT elevations occurred in 22% and were >5 times ULN in 2.2%, one dying of acute liver failure at week 12 [4 weeks after onset]).
Medrano J, Barreiro P, Tuma P, Vispo E, Labarga P, Blanco F, Soriano V. (2008). Risk for immune-mediated liver reactions by nevirapine revisited. AIDS Rev. (Review of hepatotoxicity of nevirapine; some of the risk factors identified may not apply to antiretroviral experienced patients).
Tansuphaswadikul S, Aung SE, Phonrat B, Kaewkungwal J, Pitisuttithum P, Maek-a-nantawat W. (2007). Predisposing factors for nevirapine toxicity among AIDS patients with low baseline CD4 count. Asian Pac J Allergy Immunol. (Among 206 patients with HIV infection starting regimen with nevirapine, 8 developed hepatotoxicity [4%: 3.6 per person years], higher among patients on antituberculosis drugs).
Phanuphak N, Apornpong T, Teeratakulpisarn S, Chaithongwongwatthana S, Taweepolcharoen C, Mangclaviraj S, Limpongsanurak S, et al. (2007). Nevirapine-associated toxicity in HIV-infected Thai men and women, including pregnant women. HIV Med. (409 patients [244 pregnant women] given triple therapy with nevirapine 64 [15.6%] developed hepatotoxicity, 5-fold higher rates in pregnant than nonpregnant women).
Bourlière M, Duclos-Vallée JC, Pol S. (2007). Gastroenterol Clin Biol. (Review of hepatotoxicity of antiretrovirals discussing patterns of toxic idiosyncrasy, hypersensitivity [nevirapine and abacavir], mitochondrial toxicity [zalcitabine, didanosine, stavudine and zidovudine], steatohepatitis [protease inhibitors with lipodystrophy], immune restoration [in patients with HIV-HBV or -HCV coinfection]; recommendations for management focusing on prevention and monitoring).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], and cholestatic hepatitis [many agents]).
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. (2007). Side effects of HIV therapy. J Dtsch Dermatol Ges. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide] and hyperpigmentation [zidovudine, emtricitabine]).
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. (2007). Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis. (Retrospective analysis of 132 HIV/HCV coinfected patients who were treated with interferon based therapy of whom 33% had sustained virological response; subsequent ALT elevations were less common in responders [3.1%/year] than nonresponders [12.9%/year]; events also associated with exposure to nevirapine and dideoxynucleosides).
Mussi-Pinhata MM, Rego MA, Freimanis L, Kakehasi FM, Machado DM, Cardoso EM, Read JS, NISDI Perinatal Protocol Study Group. (2007). Maternal antiretrovirals and hepatic enzyme, hematologic abnormalities among human immunodeficiency virus type 1-uninfected infants: the NISDI perinatal study. Pediatr Infect Dis J. (Analysis of serum enzyme elevations in newborns of HIV infected mothers on various antiretroviral regimens; infants whose mothers received protease inhibitors were more likely to have ALT elevations [odds ratio 1.9] similarly for nonnucleoside reverse transcriptase inhibitors [odds ratio 2.4], most elevations were mild and self-limited).
Torti C, Costarelli S, De Silvestri A, Quiros-Roldan E, Lapadula G, Cologni G, Paraninfo G, et al., BHCC Study Group. (2007). Analysis of severe hepatic events associated with nevirapine-containing regimens: CD4+ T-cell count and gender in hepatitis C seropositive and seronegative patients. Drug Saf. (Among 905 patients treated with nevirapine containing regimens, ALT elevations above 5 times ULN occurred in 7%; rates were 3 fold higher among those with HCV coinfection; among HCV negative patients, higher CD4 T cell counts and gender were risk factors for increased risk of ALT elevations).
Bae WH, Wester C, Smeaton LM, Shapiro RL, Lockman S, Onyait K, Thior I, et al. (2008). Hematologic and hepatic toxicities associated with antenatal and postnatal exposure to maternal highly active antiretroviral therapy among infants. AIDS. (Prospective monitoring found that only 1 of 69 infants born to antiretroviral-treated mothers and none of 109 infants born to drug therapy unexposed mothers with HIV infection developed ALT elevations > 5 times ULN during the first 7 months of life).
Black V, Rees H. (2008). Incidence of nevirapine-associated hepatitis in an antenatal clinic. S Afr Med J. (Experience in treating 329 pregnant HIV-positive women with nevirapine, lamivudine and zidovudine; 31 developed ALT elevations, but most were mild and only 3 patients had hepatitis [0.8%], all after 5 weeks and recovering with stopping).
Knobel H, Guelar A, Montero M, Carmona A, Luque S, Berenguer N, González A. (2008). Risk of side effects associated with the use of nevirapine in treatment-naïve patients, with respect to gender and CD4 cell count. HIV Med. (Retrospective analysis of 142 patients at single center who started triple therapy with nevirapine for HIV infection; neither skin rash [11.2%] nor ALT elevations [5.6%] were more common with higher CD4 T cell counts at baseline).
Wit FW, Kesselring AM, Gras L, Richter C, van der Ende ME, Brinkman K, Lange JM, et al. (2008). Discontinuation of nevirapine because of hypersensitivity reactions in patients with prior treatment experience, compared with treatment-naive patients: the ATHENA cohort study. Clin Infect Dis. (Among 3752 patients in Netherlands receiving nevirapine based combination therapy for HIV infection, 6.2% developed the hypersensitivity syndrome; occurrence correlated with female gender and high pretreatment CD4 counts).
Dart Trial Team. (2008). Twenty-four-week safety and tolerability of nevirapine vs. abacavir in combination with zidovudine/lamivudine as first-line antiretroviral therapy: a randomized double-blind trial(NORA). Trop Med Int Health. (Controlled trial in 600 Ugandan patients with CD4 counts <200 given nevirapine or abacavir [with zidovudine and lamivudine] for 24 weeks; 4.6% vs 2.3% developed hypersensitivity reaction, 7 nevirapine- but no abacavir-treated patients had ALT levels >10 times ULN, all within 8 weeks of starting).
De Lazzari E, León A, Arnaiz JA, Martinez E, Knobel H, Negredo E, Clotet B, et al. (2008). Hepatotoxicity of nevirapine in virologically suppressed patients according to gender and CD4 cell counts. HIV Med. (Metaanalysis of 4 controlled trials of nevirapine in 410 experienced patients, hepatotoxicity developed in 2% with low and 4% with high initial CD4 counts; but difference was not significant).
Antunes AM, Duarte MP, Santos PP, da Costa GG, Heinze TM, Beland FA, Marques MM. (2008). Synthesis and characterization of DNA adducts from the HIV reverse transcriptase inhibitor nevirapine. Chem Res Toxicol. (Nevirapine is oxidized by P450 CYP 3A4 and 2B6 and products are conjugated to glucuronides and excreted in the urine; but other pathways are possible that might yield electrophilic intermediates that can bind to DNA; in this report several nevirapine-DNA adducts were characterized).
Medrano J, Barreiro P, Tuma P, Vispo E, Labarga P, Blanco F, Soriano V. (2008). Risk for immune-mediated liver reactions by nevirapine revisited. AIDS Rev. (Review; symptomatic hepatic events occur in ~5% of patients taking nevirapine, early hypersensitivity reactions occurring especially in women with CD4 counts >250 and those with HBV or HCV coinfection; late onset hepatotoxicity may be a class effect [also occurring with efavirenz]).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents; severe liver injury due to nevirapine is rare but up to 10% of patients develop ALT elevations above 5 times normal).
Sterling RK, Chiu S, Snider K, Nixon D. (2008). The prevalence and risk factors for abnormal liver enzymes in HIV-positive patients without hepatitis B or C coinfections. Dig Dis Sci. (Retrospective analysis of data on 1208 patients with HIV infection on antiretroviral therapy; mild-to-moderate ALT elevations found in 15% of HIV-mono-infected and 63% of HCV-HIV coinfected; factors associated with ALT elevations were hypertension, higher HIV RNA levels, lower CD4 counts, metabolic syndrome and absence of protease inhibitor use).
Manosuthi W, Sungkanuparph S, Tansuphaswadikul S, Chottanapund S, Mankatitham W, Chimsuntorn S, Sittibusaya C, et al. (2008). Incidence and risk factors of nevirapine-associated severe hepatitis among HIV-infected patients with CD4 cell counts less than 250 cells/microL. J Med Assoc Thai. (Among 910 patients starting on antiretroviral therapy with nevirapine with low CD4 counts, 10 [1.2/100 patient years] developed “clinical hepatitis”, major risk factor being elevations in AST at baseline).
Sathia L, Obiorah I, Taylor G, Kon O, O'Donoghue M, Gibbins S, Walsh J, et al. (2008). Concomitant use of nonnucleoside analogue reverse transcriptase inhibitors and rifampicin in TB/HIV type 1-coinfected patients. AIDS Res Hum Retroviruses. (Among 103 HIV positive patients with tuberculosis receiving rifampin, including 17 on nevirapine and 26 efavirenz, transient elevations in ALT occurred in 17%, but only 2 patients stopped therapy for ALT elevations >5 times ULN, and both safely restarted antituberculosis therapy after ALT abnormalities resolved).
van Schalkwyk JE, Alimenti A, Khoo D, Maan E, Forbes JC, Burdge DR, Gilgoff S, et al. (2008). Serious toxicity associated with continuous nevirapine-based HAART in pregnancy. BJOG. (Analysis of 103 HIV-positive pregnant women, toxicities requiring discontinuation occurred in 6 of 56 women on nevirapine [3 rash and 3 hepatotoxicity] vs only 1 of 47 treated with other agents [kidney stones: indinavir]).
Brück S, Witte S, Brust J, Schuster D, Mosthaf F, Procaccianti M, Rump JA, et al. (2008). Hepatotoxicity in patients prescribed efavirenz or nevirapine. Eur J Med Res. (Among 151 patients starting efavirenz and 145 nevirapine, rates of ALT elevations were similar in the two groups; 6% vs 3.4% had ALT levels >2.5 times ULN and 1.2% vs 2.1% had ALT >5 times ULN; only predictive factor identified was presence of HBsAg; no fatal cases).
Chen J, Mannargudi BM, Xu L, Uetrecht J. (2008). Demonstration of the metabolic pathway responsible for nevirapine-induced skin rash. Chem Res Toxicol. (Rat model of skin rash induced by nevirapine; sex and strain dependent, onset after several weeks and more rapid with rechallenge even at lower dose; correlation between plasma levels and frequency of rash by strain and species; thus dose related and apparently due to 12-hydroxylation pathway possibly a quinone methide reactive metabolite).
Kumarasamy N, Venkatesh KK, Cecelia AJ, Devaleenal B, Lai AR, Saghayam S, Balakrishnan P, Yepthomi T, Poongulali S, Flanigan TP, Solomon S, Mayer KH. (2008). Spectrum of adverse events after generic HAART in southern Indian HIV-infected patients. AIDS Patient Care STDS. (Among 3154 patients with HIV infection treated with antiretroviral agents over a 4 year period at a single center in Southern India, hepatitis occurred in 3.5%, usually within the first 3 months; lactic acidosis was more common in women and was associated with stavudine use).
Vitezica ZG, Milpied B, Lonjou C, Borot N, Ledger TN, Fefebvre A, Hovnanian A. (2008). HLA-DRB*01 associated with cutaneous hypersensitivity induced by nevirapine and efavirenz. AIDS. (Among 21 patients with HIV infection treated with nevirapine [n=14] or efavirenz [n=7], 6 developed a hypersensitivity rash, 5 of whom had DRB1*01 compared to 1 [7%] control).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Updated recommendations on use of antiviral therapy in adults with HIV infection, including use of recently approved agents raltegravir, maraviroc and etravirine).
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes: problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirenz and 4 miscellaneous combinations).
Van Dyke RB, Wang L, Williams PL. (2008). Pediatric AIDS Clinical Trials Group 219C Team. Toxicities associated with dual nucleoside reverse-transcriptase inhibitor regimens in HIV-infected children. J Infect Dis. (Among 2233 children receiving two nucleoside reverse transcriptase inhibitors, 0.6-1.6% developed hepatitis, 8.3-13.5% acidosis; overall ALT elevations were rare [<1%]).
Ingiliz P, Benhamou Y. (2009). Elevated liver enzymes in HIV monoinfected patients on HIV therapy: what are the implications?. J HIV Ther. (Review of the causes of serum enzyme elevations during antiretroviral therapy; nonnucleoside reverse transcriptase inhibitors are capable of causing a hypersensitivity reaction with liver injury arising during the first 6 weeks of therapy as well as an immunologically mediated injury that arises 6-12 months after starting treatment).
Moodie EEM, Pai NP, Klein MB. (2009). Is antiretroviral therapy causing long-term liver damage? A comparative analysis of HIV-mono-infected and HIV/Hepatitis C co-infected cohorts. PLOS-ONE. (Analysis of ratio of AST to platelet ratio [APRI] in cohort of HIV infected patients with [n=127] or without [n=533] HCV-coinfection; APRI values were higher in patients with HCV infection and the percentage yearly increase was greater in patients on antiretroviral therapy [3.31% for protease inhibitors, 2.18% with nonnucleoside reverse transcriptase inhibitors]. Absolute values, the role of AST vs platelet count and rates for patients not on therapy were not provided).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]).
Colafigli M, Di Giambenedetto S, Bracciale L, Fanti I, Prosperi M, Cauda R, De Luca A. (2009). Long-term follow-up of nevirapine-treated patients in a single-centre cohort. HIV Med. (Among 573 patients with HIV infection treated with nevirapine based regimens at a single Italian center, 1.9% developed ALT elevations >5 times ULN and 2.4% discontinued for liver toxicity in first year; no cases of acute liver failure).
McKoy JM, Bennett CL, Scheetz MH, Differding V, Chandler KL, Scarsi KK, Yarnold PR, et al. (2009). Hepatotoxicity associated with long- versus short-course HIV-prophylactic nevirapine use: a systematic review and meta-analysis from the Research on Adverse Drug events And Reports (RADAR) project. Drug Saf. (Metaanalysis of rates of ALT elevation >5 times ULN during short [<5 days] vs longer courses of nevirapine for prophylaxis found lower rates after acute exposures [0% vs 13%] and in mothers [0.2% vs 4.4%] and their newborns [0.8% vs 1.1%]; review of MedWatch revealed 3 severe cases in non-HIV infected and 5 deaths in pregnant women attributed to nevirapine).
Ouyang DW, Shapiro DE, Lu M, Brogly SB, French AL, Leighty RM, Thompson B, et al. (2009). Increased risk of hepatotoxicity in HIV-infected pregnant women receiving antiretroviral therapy independent of nevirapine exposure. AIDS. (Among 1229 pregnant and 821 nonpregnant women with HIV infection on antiretroviral therapy, ALT elevations >5 times ULN occurred in 1.2% of pregnant vs 0.6% of nonpregnant and 0.8% of nevirapine vs 1.0% of non-nevirapine taking women).
Ouyang DW, Brogly SB, Lu M, Shapiro DE, Hershow RC, French AL, Leighty RM, et al. (2010). Lack of increased hepatotoxicity in HIV-infected pregnant women receiving nevirapine compared with other antiretrovirals. AIDS. (Among 1229 pregnant women with HIV infection treated with antiretroviral therapy during pregnancy, ALT elevations >5 times ULN occurred in 0.5% on nevirapine based vs 1.4% of 1011 on non-nevirapine based regimens; no maternal deaths from liver disease).
Peters PJ, Stringer J, McConnell MS, Kiarie J, Ratanasuwan W, Intalapaporn P, Potter D, et al. (2010). Nevirapine-associated hepatotoxicity was not predicted by CD4 count ≥250 cells/μL among women in Zambia, Thailand and Kenya. HIV Med. (Among 820 women with HIV infection started on nevirapine based regimens in 3 African countries between 2005-7, 41 [5%] developed ALT elevations >5 times ULN, 27 [3%] had rash and ALT elevations, and 3 [0.4%] died of acute liver failure; no correlation with CD4 counts, age or BMI).
Jao J, Sturdevant M, del Rio Martin J, Schiano T, Fiel MI, Huprikar S. (2010). Nevirapine-induced Stevens Johnson-syndrome and fulminant hepatic failure requiring liver transplantation. Am J Transplant. (57 year old woman with HIV infection developed rash within 3 weeks and Stevens-Johnson syndrome with jaundice within 5 weeks of switching from tenofovir to nevirapine [peak bilirubin 24 mg/dL, ALT 2150 U/L, Alk P 285 U/L, INR 2.8], progressing to hepatic failure as rash improved, requiring liver transplantation).
Coffie PA, Tonwe-Gold B, Tanon AK, Amani-Bosse C, Bédikou G, Abrams EJ, Dabis F, Ekouevi DK. (2010). Incidence and risk factors of severe adverse events with nevirapine-based antiretroviral therapy in HIV-infected women. MTCT-Plus program, Abidjan, Côte d'Ivoire. BMC Infect Dis. (Among 290 African women starting nevirapine based regimen for HIV infection, 3.4% developed ALT elevations >5 times ULN, but without relationship to initial CD4 counts).
Antela A, Ocampo A, Gómez R, López MJ, Mariño A, Losada E, Rodríguez R, et al., Galician HIV Study Group. (2010). Liver toxicity after switching or simplifying to nevirapine-based therapy is not related to CD4 cell counts: results of the TOSCANA study. HIV Clin Trials. (Among 221 patients with HIV infection on antiretroviral therapy who were switched to nevirapine, 6.6% developed ALT elevations >5 times ULN; no correlation with initial CD4 count or gender, but higher rate in those with HCV coinfection [12.9%]).
Chu KM, Boulle AM, Ford N, Goemaere E, Asselman V, Van Cutsem G. (2010). Nevirapine-associated early hepatotoxicity: incidence, risk factors, and associated mortality in a primary care ART programme in South Africa. PLoS One. (Among 1809 patients with HIV infection starting nevirapine based regimens, 26 [1.4%] developed ALT elevations >5 times ULN within 3 months, half symptomatic, none fatal, most resolving after switch to efavirenz; no association found with initial CD4 counts).
Moses M, Zachariah R, Tayler-Smith K, Misinde D, Foncha C, Manzi M, Bauerfeind A, et al. (2010). Outcomes and safety of concomitant nevirapine and rifampicin treatment under programme conditions in Malawi. Int J Tuberc Lung Dis. (Among 156 African patients with HIV infection and tuberculosis starting treatment with stavudine, lamivudine and nevirapine and given isoniazid, rifampin and pyrazinamide for tuberculosis, ALT elevations >5 times ULN developed in only one patient and none had clinically apparent liver injury).
Ciccacci C, Borgiani P, Ceffa S, Sirianni E, Marazzi MC, Altan AM, Paturzo G, et al. (2010). Nevirapine-induced hepatotoxicity and pharmacogenetics: a retrospective study in a population from Mozambique. Pharmacogenomics. (Case controlled analysis of ABC B1 and CYP single nucleotide polymorphisms [SNPs] in 78 African patients with nevirapine hepatotoxicity and 78 without; found an ABC B1 SNP associated with hepatotoxicity [p=0.04] and several CYP 2B6 SNPs associated with ALT [but not AST] elevations).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir).
Li ZC, Li HJ, Dai LL, Gao YQ, Cai WP, Li HY, Huang XJ, et al. (2010). Liver injury in HIV-1-infected patients receiving non-nucleosides reverse transcriptase inhibitors-based antiretroviral therapy. Chin Med J (Engl). (Among 75 Chinese patients on antiretroviral therapy with nevirapine or efavirenz, 45 developed abnormal liver tests, most of which were transient and mild, and risk factors included HBV or HCV coinfection, use of nevirapine and exposure to other hepatotoxic agents).
Dejesus E, Mills A, Bhatti L, Conner C, Storfer S. (2011). A randomised comparison of safety and efficacy of nevirapine vs. atazanavir/ritonavir combined with tenofovir/ emtricitabine in treatment-naïve patients. Int J Clin Pract. (Among 152 patients with HIV infection treated with nevirapine vs atazanavir/ritonavir, 1 patient in each group discontinued therapy for liver injury [enzyme elevations and jaundice).
Mankhatitham W, Lueangniyomkul A, Manosuthi W. (2011). Hepatotoxicity in patients co-infected with tuberculosis and HIV-1 while receiving non-nucleoside reverse transcriptase inhibitor-based antiretroviral therapy and rifampicin-containing anti-tuberculosis regimen. Southeast Asian J Trop Med Public Health. (Among 134 patients with HIV infection and tuberculosis treated with rifampin, ALT elevations >5 times ULN occurred in 3 patients on nevirapine [4.6%] and 1 [1.4%] on efavirenz).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, none were attributed to an antiretroviral agent).
Wang J, Kou H, Fu Q, Han Y, Qiu Z, Zuo L, Li Y, et al. (2011). Nevirapine plasma concentrations are associated with virologic response and hepatotoxicity in Chinese patients with HIV infection. PLoS One. (Analysis of nevirapine plasma levels in 227 patients found a weak correlation of higher levels with grade 3 hepatotoxicity, but only in males).
Anwikar SR, Bandekar MS, Smrati B, Pazare AP, Tatke PA, Kshirsagar NA. (2011). HAART induced adverse drug reactions: a retrospective analysis at a tertiary referral health care center in India. Int J Risk Saf Med. (Among 1844 patients treated for HIV infection at a single Indian health center, 12% reported at least one adverse event).
Htun WL, Bowonwatanuwong C, Phonrat B, Pitisuttithum P. (2012). Long term outcomes of nevirapine containing antiretroviral therapy at a center in Thailand. Southeast Asian J Trop Med Public Health. (Among 285 patients treated with nevirapine for HIV infection at a single center in Thailand, 10 [4%] had elevated liver enzymes before and only 5 [2%] after 5 years of treatment).
Chu KM, Manzi M, Zuniga I, Biot M, Ford NP, Rasschaert F, Zachariah R. (2012). Nevirapine- and efavirenz-associated hepatotoxicity under programmatic conditions in Kenya and Mozambique. Int J STD AIDS. (Among 5832 African patients starting nevirapine or efavirenz based antiretroviral therapy for HIV infection, 124 [(2.4%] developed ALT or AST elevations >5 times ULN, mostly within the first 6 months; mortality rates were the same in patients with [5.7%] and without [5.2%] liver enzyme abnormalities).
Macías J, Neukam K, Mallolas J, López-Cortés LF, Cartón JA, Domingo P, Moreno S, et al., COINS Study Team. (2012). Liver toxicity of initial antiretroviral drug regimens including two nucleoside analogs plus one non-nucleoside analog or one ritonavir-boosted protease inhibitor in HIV/HCV-coinfected patients. HIV Clin Trials. (Among 745 Spanish patients with HIV infection started on antiretroviral therapy [with 0.8-3 years of follow up], hepatotoxicity requiring discontinuation occurred in 13% on nevirapine, 4% on efavirenz, and 6% on protease inhibitors).
Lopez-Delgado JC, Mendiluce RM, Pinol TS, Fernández XP, Sanchez L, Vicente RG. (2012). Urgent liver transplantation for nevirapine-induced acute liver failure: report of a case and review of the literature. Ann Transplant. (40 year old woman with HIV infection on long term antiretroviral therapy developed fever and jaundice 4 weeks after addition of nevirapine [bilirubin 5.0 mg/dL, ALT 5200 U/L, GGT 258 U/L, INR 4.5], progressing to hepatic failure and liver transplant).
Van Welzen B, Mudrikova T, Arends J, Hoepelman A. (2012). No increased risk of hepatotoxicity in long-term use of nonnucleoside reverse transcriptase inhibitors in HIV-infected patients. HIV Med. (Rates of hepatotoxicity were similar in patients on nevirapine or efavirenz based [14.8%] as on protease inhibitor based [18.5%] antiretroviral regimens, abnormalities occurring mostly during the first year and the major risk factor being HCV coinfection).
Dong BJ, Zheng Y, Hughes MD, Frymoyer A, Verotta D, Lizak P, Sawe F, Currier JS, Lockman S, Aweeka FT, AIDS Clinical Trials Group Study 5208 Team. (2012). Nevirapine pharmacokinetics and risk of rash and hepatitis among HIV-infected sub-Saharan African women. AIDS. (Among 359 women started on a nevirapine based antiretroviral regimen, 54% developed rash and 23% ALT elevations [.5 times ULN in 3%]; rash but not ALT elevations could be related to drug levels; risk factors included higher CD4 counts).
Snijdewind IJ, Smit C, Godfried MH, Nellen JF, de Wolf F, Boer K, van der Ende ME. (2012). HCV coinfection, an important risk factor for hepatotoxicity in pregnant women starting antiretroviral therapy. J Infect. (Among 425 pregnant and 1120 nonpregnant women starting antiretroviral therapy, 77 [5%] developed ALT or AST elevations >5 times ULN; risk factors being HCV coinfection [OR 5.5] and nevirapine [OR 2.0], but not pregnancy).
Liptrott NJ, Pushpakom S, Wyen C, Fätkenheuer G, Hoffmann C, Mauss S, Knechten H, et al., German Competence Network for HIV/AIDS. (2012). Association of ABCC10 polymorphisms with nevirapine plasma concentrations in the German Competence Network for HIV/AIDS. Pharmacogenet Genomics. (Study of intracellular accumulation of nevirapine in cell culture focusing on the role of the ABC C10 transporter suggesting that variation in drug levels may be related to genetic variations in this transporter).
Wongkitisophon P, Chanprapaph K. (2012). attanakaemakorn P, Vachiramon V. Six-year retrospective review of drug reaction with eosinophilia and systemic symptoms. Acta Derm Venereol. (Among 27 patients with DRESS syndrome seen between 2005 and 2010 at a single tertiary referral center in Thailand, 26 [96%] had liver involvement and 9 [33%] were jaundiced; 4 [15%] were attributed to nevirapine, 10 [37%] phenytoin, 4 [15%] sulfonamides, and 3 [11%] allopurinol).
Carr DF, Chaponda M, Jorgensen AL, Castro EC, van Oosterhout JJ, Khoo SH, Lalloo DG, et al. (2013). Association of human leukocyte antigen alleles and nevirapine hypersensitivity in a Malawian HIV-infected population. Clin Infect Dis. (Among 117 HIV-infected Malawian adults with nevirapine hypersensitivity, HLA typing identified HLA-C*04:01 as a risk factor for Stevens-Johnson syndrome and toxic epidermal necrolysis).
Oppenheimer AP, Koh C, McLaughlin M, Williamson JC, Norton TD, Laudadio J, Heller T, et al. (2013). Vanishing bile duct syndrome in human immunodeficiency virus infected adults: a report of two cases. World J Gastroenterol. (Description of 2 patients with HIV infection and fatal vanishing bile duct syndrome, in neither of which the cause could be established).
Vispo E, Fernández-Montero JV, Labarga P, Barreiro P, Soriano V. (2013). Low risk of liver toxicity using the most recently approved antiretroviral agents but still increased in HIV-hepatitis C virus coinfected patients. AIDS. (Serum enzyme elevations occurred in 9% of 1982 patients with HIV infection started on antiretroviral therapy, including 17% of those with HCV coinfection and 6% of those without; highest rates occurred in those on nevirapine [23% with HCV, 8% without]).
Phillips E, Bartlett JA, Sanne I, Lederman MM, Hinkle J, Rousseau F, Dunn D, et al. (2013). Associations between HLA-DRB1*0102, HLA-B*5801, and hepatotoxicity during initiation of nevirapine-containing regimens in South Africa. J Acquir Immune Defic Syndr. (Among 385 patients with HIV infection receiving nevirapine, 66 [17%] developed liver enzyme elevations, usually within first 12 weekly; HLA testing showed a link with B*58:01 [23.5 vs 8.8%] and DRB1*01:02 [15.7% vs 3.9%]).
Zhang C, Wang W, Zhou M, Han Y, Xie J, Qiu Z, Guo F, et al. (2013). The interaction of CD4 T-cell count and nevirapine hepatotoxicity in China: a change in national treatment guidelines may be warranted. J Acquir Immune Defic Syndr. (Among 566 patients with HIV infection who were started on antiretroviral therapy, 36% developed ALT elevations which were >5 times ULN in 7.7%, which were more common among those with higher CD4 cell counts).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were due to nevirapine or other antiretroviral agents).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 3 were attributed to antiviral agents including 1 to nevirapine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] were attributed to antiretroviral agents including 2 to nevirapine).
Cornejo Castro EM, Carr DF, Jorgensen AL, Alfirevic A, Pirmohamed M. (2015). HLA-allelotype associations with nevirapine-induced hypersensitivity reactions and hepatotoxicity: a systematic review of the literature and meta-analysis. Pharmacogenet Genomics. (Systematic review of studies of HLA associations with nevirapine hepatotoxicity including HLA-B*58:01 and DRB1*01 in different populations).
Hiransuthikul A, Rattananupong T, Klaewsongkram J, Rerknimitr P, Pongprutthipan M, Ruxrungtham K. (2016). Drug-induced hypersensitivity syndrome/drug reaction with eosinophilia and systemic symptoms (DIHS/DRESS): 11 years retrospective study in Thailand. Allergol Int. (Among 52 patients with DRESS syndrome presenting at a Thai medical center between 2004 and 2004, the most common causes were phenytoin [23%], nevirapine [17%], allopurinol [15%], and amoxicillin-clavulanate [14%] with liver involvement in 95%, fever 80%, lymphadenopathy 50%, and eosinophilia 60%).
Brandariz D, Smithson A, Anton-Vazquez V. (2017). Drug reaction with eosinophilia and systemic symptoms related to antiretroviral treatment in human immunodeficiency virus patients. Indian J Sex Transm Dis AIDS. (Systematic review of literature on DRESS syndrome in HIV positive patients published between 1998 and 2017 identified 35 cases due to 5 agents: nevirapine 12, abacavir 10, efavirenz 6, raltegravir 6 and tenofovir 1; with fever in 83%, rash 83%, lymphadenopathy 34%, leukocytosis 26%, atypical lymphs 9%, eosinophilia 51%, liver involvement 80%, but no deaths).
Wu PY, Cheng CY, Liu CE, Lee YC, Yang CJ, Tsai MS, Cheng SH, et al. (2017). Multicenter study of skin rashes and hepatotoxicity in antiretroviral-naïve HIV-positive patients receiving non-nucleoside reverse-transcriptase inhibitor plus nucleoside reverse-transcriptase inhibitors in Taiwan. PLoS One. (Among 2341 Taiwanese HIV-positive patients initiating combination therapy including a non-nucleoside reverse transcriptase inhibitor between 2012 and 2015, ALT elevations above 3 times ULN developed within 4 weeks in 5.2% on nevirapine, 2.2% on efavirenz and 0.6% of rilpivirine).
Devarbhavi H, Raj S. (2019). Drug-induced liver injury with skin reactions: drugs and host risk factors, clinical phenotypes and prognosis. Liver Int. (Review of adverse drug reactions with both skin and liver injury, typically with DRESS, the major causes of which are anticonvulsants [phenytoin, carbamazepine, lamotrigine], antibiotics [sulfonamides], allopurinol, and nevirapine; often with HLA associations but differing by agent, organ involvement, and often race).
Giacomelli A, Riva A, Falvella FS, Oreni ML, Cattaneo D, Cheli S, Renisi G, et al. (2018). Clinical and genetic factors associated with increased risk of severe liver toxicity in a monocentric cohort of HIV positive patients receiving nevirapine-based antiretroviral therapy. BMC Infect Dis. (Among 362 patients receiving nevirapine for HIV infection, 8 [2.2%] developed severe hepatotoxicity, risk factors being HCV or HBV coinfection [n=7], female sex [n=6], slightly higher CD4 counts, and baseline ALT levels [median = 82 vs 27 U/L]).
Delicio AM, Lajos GJ, Amaral E, Lopes F, Cavichiolli F, Myioshi I, Milanez H. (2018). Adverse effects of antiretroviral therapy in pregnant women infected with HIV in Brazil from 2000 to 2015: a cohort study. BMC Infect Dis. (Among 793 pregnancies in women with HIV infection on antiretroviral therapy, maternal adverse effects included dyslipidemia in 92%, anemia in 56% and liver test abnormalities in 56% including hyperbilirubinemia in 12%, most of the reactions being “mild” and no deaths; highest rates in women on non-nucleoside reverse transcriptase inhibitors such as nevirapine).
Tadesse BT, Foster BA, Kabeta A, Ayalew F. (2019). Hepatic and renal toxicity and associated factors among HIV-infected children on antiretroviral therapy: a prospective cohort study. HIV Med. (Among 705 HIV-infected Ethiopian children followed on combination antiretroviral therapy, 12% had ALT elevations at baseline but mean levels decreased over time).

## OTHER REFERENCE LINKS

1 Recent References on Nevirapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nevirapine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nevirapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nevirapine)